# Ceftriaxone

## OVERVIEW

### Introduction

Ceftriaxone is a third generation cephalosporin antibiotic which has been associated with development of biliary sludge and biliary colic when given parenterally and in high doses. Ceftriaxone is also associated with rare instances of immunoallergic, usually cholestatic hepatitis similar to the injury associated with other cephalosporins.

### Background

Ceftriaxone (sef" trye ax' one) is a third generation cephalosporin was approved for use in the United States in 1984, and it continues to be widely used. Ceftriaxone is available in a parenteral formulation generically and under the brand name of Rocephin. It can be given either intravenously or intramuscularly and is indicated for therapy of moderate-to-severe bacterial infections caused by susceptible organisms. Typical dose regimens in adults are 1 to 2 grams given im or iv in one or two divided doses daily for 7 to 14 days. The parenteral cephalosporins are widely used in medicine for serious infections and can be safely given to patients with advanced liver disease, dose modifications being required mainly for renal insufficiency. Ceftriaxone is also approved for use in children. Ceftriaxone is generally well tolerated; adverse events can include diarrhea, nausea, abdominal pain, dyspepsia, headache, and rash. Rare but potentially severe adverse events include Clostridium difficile-associated diarrhea, hypersensitivity reactions, angioedema, anaphylaxis and Stevens Johnson syndrome/toxic epidermal necrolysis.

### Hepatotoxicity

Parenteral administration of ceftriaxone has been associated with development of biliary sludge in 3% to 46% of patients. The incidence may be higher in children than adults and is associated with higher doses and longer courses of treatment and possibly with fasting or dehydration. The syndrome is referred to as “pseudolithiasis” as the sludge and stones consist largely of ceftriaxone and they resolve spontaneously when the drug is stopped, indicating that surgery can be avoided. Most cases occur with minimal or no symptoms. Frank symptoms of cholecystitis are reported in up to 5% of patients who develop pseudo-lithiasis. Typically, serum enzymes and bilirubin levels remain normal even with biliary colic, but in rare instances there is cholestatic jaundice or gallstone pancreatitis that can be severe and require surgical intervention. Sludge and symptoms of gallbladder disease can arise within a few days of starting therapy, but typically resolve rapidly once ceftriaxone is stopped, although sludge and gallstones may be detectable by ultrasound for several months.

Ceftriaxone can also lead to an immunoallergic form of cholestatic hepatitis similar to what has been described with other cephalosporins. This reaction is idiosyncratic and is very rare. Symptoms of abdominal pain, nausea, pruritis and jaundice arise within 1 to 4 weeks of initiation of therapy and may worsen for 1 to 2 weeks after stopping the antibiotic. A cholestatic pattern of serum enzyme elevations and immunoallergic features of fever, rash and eosinophilia are common. The injury is usually mild and self-limited.

Likelihood score: B (ceftriaxone is a very likely cause of clinically apparent liver injury and can also lead to biliary sludge and “pseudolithiasis” caused by crystallization of ceftriaxone in bile present in the gallbladder or biliary tree).

### Mechanism of Injury

The mechanism of biliary sludge formation during ceftriaxone therapy appears to be the propensity of ceftriaxone to bind calcium and form insoluble crystals in bile in the gallbladder, resulting in biliary sludge or frank stones. This complication is not idiosyncratic, being demonstrable in animal models. In a similar manner, calcium salts of ceftriaxone can precipitate in urine and lead to sludge in ureters or bladder that are capable of causing urinary obstruction or symptomatic kidney and bladder stones. The rare, idiosyncratic acute cholestatic liver injury linked to ceftriaxone is probably due to hypersensitivity.

### Outcome and Management

In most case reports, recovery has been rapid within 1 to 2 weeks, but some patients have required cholecystectomy during the acute illness and stones or sludge may persist for up to several months. The immunoallergic form of cholestatic hepatitis generally resolves rapidly and has not been associated with acute liver failure or chronic injury.

Drug Class: Antiinfective Agents, Cephalosporins

## CASE REPORT

### Case 1. Biliary sludge and cholestatic hepatitis during intravenous administration of ceftriaxone.(1)

A 73 year old woman with rheumatoid arthritis developed nausea and right upper quadrant pain on the twelfth day of therapy with iv ceftriaxone for Klebsiella sepsis. A DISIDA scan demonstrated nonvisualization of the gallbladder and no excretion after 4 hours, suggesting common bile duct obstruction. Serum enzymes and amylase levels, which had been normal on admission, were increased. Abdominal ultrasound showed multiple small calculi in the gallbladder, but no biliary dilatation. Ultrasound done early during the hospitalization (for evaluation of renal disease) had shown a normal gallbladder without stones. Ceftriaxone was stopped a few days later and her abdominal pain and nausea improved promptly. Four days later, amylase and ALT levels were normal. Four weeks later, ultrasound demonstrated disappearance of the gallstones and alkaline phosphatase levels were normal.

#### Key Points

Medication: | Ceftriaxone, 1.0 gram iv every 12 hours for 14 days
Pattern: | Cholestatic (R=1.7)
Severity: | 1+ (no jaundice)
Latency: | 12 days
Recovery: | Complete in 4 weeks
Other medications: | Piroxicam, ranitidine, furosemide, thyroxine, vitamin D, calcium

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
Pre | | 51 | 103 | 0.2 | Admission for GI bleeding
0 | | Ceftriaxone started (day 7 of hospitalization)
12 days | | Abdominal pain and nausea: gallbladder sludge
13 days | | 92 | 183 | 0.4 | Amylase 513
14 days | | 252 | 299 | Normal | Ceftriaxone stopped
18 days | 4 days | 52 | 245 | | Ultrasound: single gallstone
6 weeks | 4 weeks | Normal | Normal | Normal | Ultrasound: no gallstones
Normal Values | | Not given | | <1.2

#### Comment

Only 5% to 10% of patients who develop biliary sludge (pseudolithiasis) during ceftriaxone therapy develop symptoms of biliary colic and, even with symptoms, patients rarely develop elevations of serum enzymes or bilirubin levels. The case described above developed what appeared to be a gallstone pancreatitis and partial biliary obstruction leading to mild elevations in serum aminotransferase and alkaline phosphatase levels, but without jaundice. The development of ceftriaxone biliary stones during therapy and dissolution afterwards was nicely documented in this case report. The biliary symptoms resolved with a day or two and the stones within 4 weeks of stopping therapy.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Ceftriaxone – Generic, Rocephin®

DRUG CLASS

Antiinfective Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Ceftriaxone)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Ceftriaxone Sodium | 74578-69-1 | C18-H18-N8-O7-S3.2Na

## CITED REFERENCES

1 Modified from. (1991). Zinberg J, Chernaik R, Coman E, Rosenblatt R, Brandt LJ. Reversible symptomatic biliary obstruction associated with ceftriaxone pseudolithiasis. Am J Gastroenterol.

## ANNOTATED BIBLIOGRAPHY

References updated: 20 December 2021

Zimmerman HJ. Cephalosporins. In, Hepatotoxicity: The Adverse Effects of Drugs and Other Chemicals on the Liver. 2nd Ed. Philadelphia: Lippincott, 1999. p. 589-92. (Expert review of cephalosporins and liver injury published in 1999).
Moseley RH. Hepatotoxicity of antimicrobials and antifungal agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013. p. 463-83. (Review of cephalosporin induced liver injury mentions that ceftriaxone has been linked to biliary sludge and concretions and with occasional reports of cholestatic hepatitis).
Petri WA Jr. Penicillins, cephalosporins, and other ß-lactam antibiotics. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's The pharmacological basis of therapeutics, 12th ed. New York: McGraw-Hill, 2011: 1477-1504. (Textbook of pharmacology and therapeutics).
File TM, Tan JS, Salstrom SJ. (1984). Clinical evaluation of ceftriaxone. Clin Ther. (Analysis of 77 patients receiving ceftriaxone for serious infections; 93% efficacy; ALT elevations in 8 [10%, peak levels 92 U/L] ).
Oakes M, MacDonald H, Wilson D. (1984). Abnormal laboratory test values during ceftriaxone therapy. Am J Med. (Analysis of laboratory test abnormalities among 2640 patients receiving ceftriaxone for 1 day to 6 weeks at varying doses in prelicensure studies; ALT elevations occurred in 3.1%, Alk P 1.0% and bilirubin in 0.3%; rates that were similar to those of other iv cephalosporins; one case had ALT elevations with jaundice which resolved ultimately, but was not otherwise characterized).
Moskovitz BL. (1984). Clinical adverse effects during ceftriaxone therapy. Am J Med. (Review of adverse effects of ceftriaxone in prelicensure studies; 2640 patients in 153 studies, allergic reactions in 3%; jaundice in 2 patients, both of whom were septic and resolved with stopping therapy; no mention of biliary cholic).
Parry MF. (1984). Toxic and adverse reactions encountered with new beta-lactam antibiotics. Bull N Y Acad Med. (Review suggesting that hepatitis occurs in "2-5%" of cephalosporin- and penicillin treated patients).
Barson WJ, Miller MA, Brady MT, Powell DA. (1985). Prospective comparative trial of ceftriaxone vs. conventional therapy for treatment of bacterial meningitis in children. Pediatr Infect Dis. (Trial comparing ceftriaxone to ampicillin with chloramphenicol for meningitis in 50 children; similar efficacy, more diarrhea with ceftriaxone and 11% had minor ALT elevations, returning to normal during or after therapy).
Schaad UB, Tschäppeler H, Lentze MJ. (1986). Transient formation of precipitations in the gallbladder associated with ceftriaxone therapy. Pediatr Infect Dis. (Initial report of transient biliary sludge in a 18 year old male with chronic granulomatous disease receiving iv ceftriaxone, who was found to have gallbladder abnormalities incidentally while being followed for a splenic abscess with repeat ultrasound examinations; the stones appeared during therapy and resolved soon after ceftriaxone was stopped).
Norrby SR. (1987). Side effects of cephalosporins. Drugs. (Clinical review of cephalosporins: ALT elevations occur in 1-8% of treated patients, but clinically apparent hepatitis is rare, usually occurring with allergic symptoms; little evidence for cross hypersensitivity with penicillins).
Schaad UB, Wedgwood-Krucko J, Tschäppeler H. (1988). Reversible ceftriaxone-associated biliary pseudolithiasis in children. Lancet. (Prospective ultrasound study of 37 children receiving ceftriaxone; 16 [43%] developed sludge and 1 urolithiasis in 4 to 22 days, 3 [8%] symptomatic, all resolved in 2-63 days; referred to syndrome as "biliary pseudolithiasis").
Jacobs RF. (1988). Ceftriaxone-associated cholecystitis. Pediatr Infect Dis J. (16 year old girl given 2 g ceftriaxone iv twice daily, and 3 days later developed biliary colic with raised GGT [184 U/L], resolved in 8 weeks).
Meyboom RH, Kuiper H, Jansen A. (1988). Ceftriaxone and reversible cholelithiasis. BMJ. (Two cases of biliary colic in adults during ceftriaxone therapy, both resolved; cholecystectomy later in one showed no stones and no abnormalities of gallbladder).
Pigrau C, Pahissa A, Gropper S, Sureda D, Martinez Vazquez JM. (1989). Ceftriaxone-associated biliary pseudolithiasis in adults. Lancet. (Prospective ultrasound study in 20 adults receiving iv ceftriaxone; 5 [25%] developed stones by 4-17 days, all resolving in 7-26 days, serum enzymes normal and no symptoms; stones correlated with total ceftriaxone dose [5-80 g]).
Cometta A, Gallot-Lavallée-Villars S, Iten A, Cantoni L, Anderegg A, Convers JJ, Glauser MP. (1990). Incidence of gallbladder lithiasis after ceftriaxone treatment. J Antimicrob Chemother. (Prospective study of 34 patients given amoxicillin/clavulanate vs 40 given ceftriaxone; follow up 6 and 12 months later showed only one gallstone - in an amoxicillin/clavulanate treated patient; ultrasound not done during therapy).
Heim-Duthoy KL, Caperton EM, Pollock R, Matzke GR, Enthoven D, Peterson PK. (1990). Apparent biliary pseudolithiasis during ceftriaxone therapy. Antimicrob Agents Chemother. (Prospective study in 28 adults on iv ceftriaxone and 8 controls for 14 days found abnormalities in 6 [21%] treated and 1 [12%] controls after 14 days; 2 were symptomatic, all resolved spontaneously within 9 to 26 days).
Shiffman ML, Keith FB, Moore EW. (1990). Pathogenesis of ceftriaxone-associated biliary sludge. In vitro studies of calcium-ceftriaxone binding and solubility. Gastroenterology. (Ceftriaxone binds calcium in vitro and forms precipitations when added at high concentrations to human bile).
Schaad UB, Suter S, Gianella-Borradori A, Pfenninger J, Auckenthaler R, Bernath O, Cheseaux JJ, et al. (1990). A comparison of ceftriaxone and cefuroxime for treatment of bacterial meningitis in children. N Engl J Med. (Prospective study comparing ceftriaxone and cefuroxime in 106 children with meningitis; all were cured; ultrasound identified sludge in 16 of 35 treated with ceftriaxone, but none in 35 cefuroxime treated children after 3-10 days; sludge resolved completely in 11 to 63 days after therapy; 3 [9%] had colic).
Fekety FR. (1990). Safety of parenteral third-generation cephalosporins. Am J Med. (Review article stating that aminotransferase elevations can occur on cephalosporin therapy, but clinically apparent liver disease is rare).
Lopez AJ, O'Keefe P, Morrissey M, Pickleman J. (1991). Ceftriaxone-induced cholelithiasis. Ann Intern Med. (Patient on iv ceftriaxone for endocarditis for unclear period of time developed pancreatitis and later underwent cholecystectomy demonstrating five soft, green ceftriaxone stones).
Zinberg J, Chernaik R, Coman E, Rosenblatt R, Brandt LJ. (1991). Reversible symptomatic biliary obstruction associated with ceftriaxone pseudolithiasis. Am J Gastroenterol. (73 year old woman with multiple medical problems developed biliary colic and pancreatitis [peak amylase 513 U/L] after 12 days of iv ceftriaxone for Klebsiella sepsis, with mild elevations in Alk P [299 U/L] and ALT [252 U/L], but no jaundice, resolving once ceftriaxone was stopped: Case 1).
Park HZ, Lee SP, Schy AL. (1991). Ceftriaxone-associated gallbladder sludge. Identification of calcium-ceftriaxone salt as a major component of gallbladder precipitate. Gastroenterology. (Surgical specimens from 4 patients with biliary sludge after ceftriaxone therapy showed no stones, but rather granular-crystalline material of cholesterol [2%], bilirubin [14%] and calcium-ceftriaxone).
Kim YS, Kestell MR, Lee SP. (1992). Gall-bladder sludge: lessons from ceftriaxone. J Gastroenterol Hepatol. (Review and discussion of pathogenesis of ceftriaxone associated biliary sludge and stone formation).
Riccabona M, Kerbl R, Schwinger W, Spork D, Millner M, Grubbauer HM. (1993). Klin Padiatr. (Among 43 children receiving iv ceftriaxone, 20 developed sludge by ultrasound within 10 days, 2 developing serum enzyme abnormalities, another 3 had severe pain, but all resolved within 2 months).
Kirejczyk WM, Crowe HM, Mackay IM, Quintiliani R, Cronin EB. (1992). Disappearing “gallstones”: biliary pseudolithiasis complicating ceftriaxone therapy. AJR Am J Roentgenol. (19 year old woman with Lyme disease developed biliary colic 1 week after starting a 14 day course of iv ceftriaxone; had symptoms of fever and colic with gallstones on ultrasound that resolved in the next 3 weeks without therapy).
Michielsen PP, Fierens H, Van Maercke YM. (1992). Drug-induced gallbladder disease. Incidence, aetiology and management. Drug Saf. (Review article on drug induced gallbladder disease focusing upon estrogens, clofibrate, ceftriaxone, octreotide, and hepatic artery chemotherapy).
Thompson JW, Jacobs RF. (1993). Adverse effects of newer cephalosporins. An update. Drug Saf. (Extensive review; transient increases in ALT, AST or Alk P have been reported in 0.7%, 6%, 11% and 28% of prospectively followed patients treated with various cephalosporins; clinically significant biliary sludging with ceftriaxone, particularly in children, not found with other cephalosporins).
Blais C, Duperval R. (1994). Biliary pseudolithiasis in a child associated with 2 days of ceftriaxone therapy. Pediatr Radiol. (18 month old boy given iv ceftriaxone for 2 days, developed biliary colic on day 5, normal gallbladder and no stones found on cholecystectomy on day 11).
Barzilai M. (1994). Harefuah. (Case series of 2 children who developed symptoms and gallbladder sludge on ceftriaxone therapy; resolved with discontinuation).
Di Martino V, Cadranel JF, Attali P. (1994). Gastroenterol Clin Biol. (Review of hepatobiliary complications of cephalosporins mentioning rare case reports of hepatotoxicity and issue of pseudolithiasis with ceftriaxone).
Ettestad PJ, Campbell GL, Welbel SF, et al. (1995). Biliary complications in the treatment of unsubstantiated Lyme disease. J Infect Dis. (Case control study in a hospital that reported 1730 admissions for therapy of Lyme disease; among 1352 patients, 24 developed gallstone disease and 14 had cholecystectomy; all had received iv ceftriaxone).
Stabile A, Ferrara P, Marietti G, Maresca G. (1995). Ceftriaxone-associated gallbladder lithiasis in children. Eur J Pediatr. (Prospective study of 41 children receiving iv ceftriaxone; 5 [12%] developed stones/sludge, one with symptoms, all resolved in 10-30 days).
Benedetti M, Zanchetta S, Bagnani A, Praderio R, Perbellini S, Melo C. (1995). Pediatr Med Chir. (1 year old child developed symptomatic pseudolithiasis during iv ceftriaxone therapy, which resolved within 4 weeks of stopping).
George DK, Crawford DH. (1996). Antibacterial-induced hepatotoxicity. Incidence, prevention and management. Drug Saf. (Review of hepatotoxicity from antibiotics with one sentence on cephalosporins, describing liver injury from this class as being extremely rare, although elevations in aminotransferases occurred in 0.7-11% of treated patients).
Robertson FM, Crombleholme TM, Barlow SE, Verhave M, Brown D. (1996). Ceftriaxone choledocholithiasis. Pediatrics. (9 year old boy given 7 day course of iv ceftriaxone, developed biliary colic 5 days later, abnormal Alk P [335 U/L] and biliary dilatation on ultrasound; surgery found ceftriaxone stone in common bile duct).
Kong MS, Chen CY. (1996). Risk factors leading to ceftriaxone-associated biliary pseudolithiasis in children. Changgeng Yi Xue Za Zhi. (Prospective ultrasound study in 151 children receiving iv ceftriaxone; 5 [3%] developed asymptomatic pseudolithiasis after 3-7 days; risk factors were fasting and older age).
Longo F, Hastier P, Buckley MJ, Chichmanian RM, Delmont JP. (1998). Acute hepatitis, autoimmune hemolytic anemia, and erythroblastocytopenia induced by ceftriaxone. Am J Gastroenterol. (Elderly man developed jaundice with mixed enzyme elevations 3 days after a 12 day course of oral ceftriaxone; bilirubin 22 times, ALT 11 times and Alk P 6 times ULN, later developed severe hemolytic anemia requiring prednisone and resolving only by six months).
Maranan MC, Gerber SI, Miller GG. (1998). Gallstone pancreatitis caused by ceftriaxone. Pediatr Infect Dis J. (13 year old developed pancreatitis 4 days after stopping 5 weeks of ceftriaxone with several other antibiotics; amylase 1133 U/L but normal ALT. Cholecystectomy showed stones and chronic cholecystitis; analysis of stone showed "100%"ceftriaxone).
Herek O, Sarioğlu A, Koçer N, Tiryaki A, Akkemik B. (1999). Biliary pseudolithiasis in childhood: a case report. Eur J Pediatr Surg. (Case report of symptomatic biliary sludge arising after 6 days of intravenous ceftriaxone, resolving within 11 days of stopping).
Vega C, Quinby PM, Aspy CB. (1999). Hepato-biliary abnormalities secondary to ceftriaxone use: a case report. J Okla State Med Assoc. (10 month old with rotavirus infection given ceftriaxone developed elevated Alk P [3580 U/L] and AST [84 U/L] after ~7 days, normal gallbladder ultrasound, rapid recovery).
Papadopoulou F, Efremidis S, Karyda S, Badouraki M, Karatza E, Panteliadis C, Malaka K. (1999). Incidence of ceftriaxone-associated gallbladder pseudolithiasis. Acta Paediatr. (Prospective study in 44 children given iv ceftriaxone for 3 to 14 days; 11 [25%] developed pseudolithiasis after 2-9 days, 2 with symptoms [5%]; all resolved completely in 8-23 days).
de Moor RA, Egberts AC, Schröder CH. (1999). Ceftriaxone-associated nephrolithiasis and biliary pseudolithiasis. Eur J Pediatr. (7 year old boy developed urinary stone and biliary sludge after 4 days of high dose iv ceftriaxone and passed a ceftriaxone containing urinary stone after 10 days).
Bonnet JP, Abid L, Dabhar A, Lévy A, Soulier Y, Blangy S. (2000). Early biliary pseudolithiasis during ceftriaxone therapy for acute pyelonephritis in children: a prospective study in 34 children. Eur J Pediatr Surg. (Prospective study in 34 children given iv ceftriaxone with ultrasound before and at end of therapy; 5 [15%] developed asymptomatic gallstones, all resolved within 5 months).
Tuckuviene R, Myrtue GS. (2000). Ugeskr Laeger. (5 year old girl developed symptomatic pseudolithiasis on ceftriaxone, resolving rapidly with stopping).
Palanduz A, Yalçin I, Tonguç E, Güler N, Oneş U, Salman N, Somer A. (2000). Sonographic assessment of ceftriaxone-associated biliary pseudolithiasis in children. J Clin Ultrasound. (Prospective study of 118 children receiving 1-3 weeks of iv ceftriaxone found 17% developed sludge; all were asymptomatic and all resolved in 2 weeks; no risk factors observed).
Grasberger H, Otto B, Loeschke K. (2000). Ceftriaxone-associated nephrolithiasis. Ann Pharmacother. (31 year old man developed symptomatic kidney stones 8 days after starting iv ceftriaxone, resolving spontaneously).
Prince JS, Senac MO. (2003). Ceftriaxone-associated nephrolithiasis and biliary pseudolithiasis in a child. Pediatr Radiol. (14 year old boy developed nephrolithiasis with pain and hematuria and increased creatinine; both biliary and urinary sludge found, referred to as "toothpaste"; resolution in 3 weeks).
Ravisha MS, Godambe SV. (2004). Ceftriaxone induced cholestasis in a neonate: a case report. Indian J Med Sci. (17 day old male developed cholestasis after 7 days of iv ceftriaxone; sludge on ultrasound, bilirubin 2.6 mg/dL, ALT 98 U/L, Alk P 1194 U/L, resolution within 3-7 days).
Wen HH, Huang YK, Zheng GL. (2004). Ceftriaxone-associated gallbladder pseudolithiasis: report of one case. Acta Paediatr Taiwan. (5 year old boy developed cholelithiasis 5 days after starting ceftriaxone, resolving after 1 month).
Acun C, Erdem LO, Sogut A, Erdem CZ, Tomac N, Gundogdu S. (2004). Ceftriaxone-induced biliary pseudolithiasis and urinary bladder sludge. Pediatr Int. (5 year old girl developed biliary colic after 3 days of ceftriaxone; laboratory tests were normal, but ultrasound showed both gallbladder and urinary bladder sludge, resolving spontaneous within 12 days of stopping).
Acun C, Erdem LO, Söğüt A, Erdem CZ, Tomaç N, Gündoğdu S, Cavuldak S. (2004). Gallbladder and urinary tract precipitations associated with ceftriaxone therapy in children: a prospective study. Ann Trop Paediatr. (Prospective ultrasound study of 36 children given iv ceftriaxone for up to 14 days; 5 [14%] developed gallbladder and one [3%] urinary bladder stones, most were symptomatic, all resolved spontaneously).
Avci Z, Koktener A, Uras N, et al. (2004). Nephrolithiasis associated with ceftriaxone therapy: a prospective study in 51 children. Arch Dis Child. (Prospective study of 51 children with various infections treated with ceftriaxone iv or im for 5-10 days; nephrolithiasis found by ultrasound in 4 children [8%], all asymptomatic, 3 resolved in follow up; no risk factors found).
Bor O, Dinleyici EC, Kebapci M, Aydogdu SD. (2004). Ceftriaxone-associated biliary sludge and pseudocholelithiasis during childhood: a prospective study. Pediatr Int. (Prospective study of 38 children receiving iv ceftriaxone; ultrasound at 10 days showed gallstones in 29% and sludge in 8%; one child had symptoms; resolution usually occurred within 1 month, but sometimes required 3).
Evliyaoglu C, Kizartici T, Bademci G, Unal B, Keskil S. (2005). Ceftriaxone-induced symptomatic pseudolithiasis mimicking ICP elevation. Zentralbl Neurochir. (Patient developed pseudolithiasis after neurosurgery and iv ceftriaxone; made differential diagnosis difficult).
Ceran C, Oztoprak I, Cankorkmaz L, Gumuç C, Yildiz T, Koyluoglu G. (2005). Ceftriaxone-associated biliary pseudolithiasis in paediatric surgical patients. Int J Antimicrob Agents. (Prospective ultrasound study of 50 children treated with ceftriaxone after surgery; 13 [26%] developed sludge or stones within 4-22 days; resolved within 3-63 days, no enzyme elevations, no risk factors found).
Bell MJ, Stockwell DC, Luban NL, Shirey S, Shaak L, Ness PM, Wong ECC. (2005). Ceftriaxone-induced hemolytic anemia and hepatitis in an adolescent with hemoglobin SC disease. Pediatr Crit Care Med. (17 year old boy with sickle cell disease and severe hemolytic anemia given ceftriaxone developed progressive renal and hepatic failure and death; liver failure likely due to shock).
Bickford CL, Spencer AP. (2005). Biliary sludge and hyperbilirubinemia associated with ceftriaxone in an adult: case report and review of the literature. Pharmacotherapy. (Review of literature on ceftriaxone associated pseudolithiasis; case report of 53 year old man with chronic hepatitis C who developed jaundice after 7 days of iv ceftriaxone with little change in ALT or AST [bilirubin 5.8 mg/dL, ALT 41 U/L, Alk P 88 U/L], which resolved only once ceftriaxone was stopped, but role of sepsis could not be excluded).
Rivkin AM. (2005). Hepatocellular enzyme elevations in a patient receiving ceftriaxone. Am J Health Syst Pharm. (Case report and literature review; seriously ill 31 year old man in ICU had increase in ALT from 9 to 56 to 442 U/L, but normal Alk P and bilirubin and no symptoms after 7 days of ceftriaxone therapy, with resolution within 2 weeks of switching antibiotics).
Biner B, Oner N, Celtik C, Bostancioğlu M, Tunçbilek N, Güzel A, Karasalihoğlu S. (2006). Ceftriaxone-associated biliary pseudolithiasis in children. J Clin Ultrasound. (Among 156 children given iv ceftriaxone who were followed prospectively with serial abdominal ultrasounds, 27 [17%] developed biliary stones or sludge and 5 [3%] became symptomatic; resolving within 10-30 days of stopping; risk factors were older age and higher doses of ceftriaxone).
Araz N, Okan V, Demirci M, Araz M. (2007). Pseudolithiasis due to ceftriaxone treatment for meningitis in children: report of 8 cases. Tohoku J Exp Med. (Case series of 8 children with ceftriaxone induced pseudolithiasis; all resolved within 30 days).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, one case was attributed to ceftriaxone alone [85 year old man developed cholestatic hepatitis 3 weeks after a four day course of intravenous ceftriaxone]).
Peker E, Cagan E, Dogan M. (2009). Ceftriaxone-induced toxic hepatitis. World J Gastroenterol. (12 year old boy developed fatigue after 3 days of ceftriaxone therapy followed by jaundice [bilirubin 4.2 mg/dL, ALT 871 U/L, Alk P 143 U/L, 8% eosinophils], resolving within 10 weeks of stopping).
Ferrajolo C, Capuano A, Verhamme KM, Schuemie M, Rossi F, Stricker BH, Sturkenboom MC. (2010). Drug-induced hepatic injury in children: a case/non-case study of suspected adverse drug reactions in VigiBase. Br J Clin Pharmacol. (Worldwide pharmacovigilance database contained 9036 hepatic adverse drug reactions in children, 104 of which were attributed to ceftriaxone, ranking 10th in frequency and being the only cephalosporin listed).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, one of which was attributed to cefepime, but none to ceftriaxone or other cephalosporins).
Kaur I, Singh J. (2011). Cholestatic hepatitis with intravenous ceftriaxone. Indian J Pharmacol. (24 year old woman developed dark urine 24 hours after starting ceftriaxone and piroxicam and 3 days later was jaundiced [bilirubin 6.5 mg/dL, ALT 164 U/L, Alk P 580 U/L], resolving within 3 weeks of stopping both drugs).
Choi YY, Jung YH, Choi SM, Lee CS, Kim D, Hur KY. (2011). Gallbladder pseudolithiasis caused by ceftriaxone in young adult. J Korean Surg Soc. (Two men, ages 21 and 22 years, developed gallstones found by CT scan 5 and 17 days after starting ceftriaxone without symptoms or laboratory abnormalities, resolving within 1 month of stopping).
Hanata N, Imamura T, Koyama R, Koizumi Y, Tamura T, Ito J, Takeuch K. (2012). Nihon Naika Gakkai Zasshi.
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, of which 2 were attributed to cephalosporins, one with jaundice to cephalexin and one with enzyme elevations only to ceftazidime).
Rodríguez Rangel DA, Pinilla Orejarena AP, Bustacara Diaz M, Henao García L, López Cadena A, Montoya Camargo R, Moreno LA. (2014). An Pediatr (Barc). (Prospective study in 73 children receiving ceftriaxone, identified sludge or gallstones [4-14 mm in diameter] by ultrasound in 31 [43%], of whom 7 had symptoms, all resolving within 2 months of stopping, but one requiring surgery).
Zheng FY, Xing Y, Lu S, Liu DM. (2013). Zhongguo Dang Dai Er Ke Za Zhi.
Tomoda T, Ueki T, Saito S, Tatsukawa M, Nawa T, Hamamoto H, Endo H, et al. (2013). Nihon Shokakibyo Gakkai Zasshi. (47 year old woman found to have developed biliary stones and sludge on CT scan after 8 days of intravenous ceftriaxone, which disappeared within 6 days).
von Martels JZ, Van de Meeberg EK, Holman M, Ligtenberg JJ, Ter Maaten JC. Pseudolithiasis after recent use of ceftriaxone: an unexpected diagnosis in a child with abdominal pain. Am J Emerg Med 2013; 31: 1294. e5-6. (14 year old boy treated for Lyme disease with a 2 week course of iv ceftriaxone presented 4 days later with abdominal pain and biliary stones by ultrasound and ERCP [bilirubin 4.2 mg/dL, ALT 187 U/L, Alk P 398, GGT 291 U/L], resolving with conservative management within a few days and no stones found on follow-up ultrasound 4 weeks later).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, but none were attributed to ceftriaxone or a cephalosporin).
Alemayehu H, Desai AA, Thomas P, Sharp SW, St Peter SD. (2014). Ceftriaxone-induced pseudolithiasis in children treated for perforated appendicitis. Pediatr Surg Int. (Among 71 children treated with iv ceftriaxone for perforated appendicitis, 10 [14%] developed gallbladder stones or sludge, one of whom developed symptoms and underwent cholecystectomy).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: the DILIN prospective study. Gastroenterology. (Among 899 cases of drug induced liver injury seen over a ten year period at 8 U.S. medical centers, 323 [36%] were attributed to antibiotics of which 36 [4%] were cephalosporins including cefazolin [21], ceftriaxone [4], cefalexin [3], cefadroxil [2] and cefuroxime [2] and four others [1 case each]).
Alqahtani SA, Kleiner DE, Ghabril M, Gu J, Hoofnagle JH, Rockey DC, Drug-Induced Liver Injury Network (DILIN) Study Investigators. (2015). Identification and characterization of cefazolin-induced liver injury. Clin Gastroenterol Hepatol. (Among 1019 patients enrolled in a US database of drug induced liver injury between 2004 and 2012, 33 [3%] were due to cephalosporins, of which 19 presented 6-29 days after a single iv injection of cefazolin exhibiting a cholestatic pattern of injury, mild immunoallergic features, moderate severity and invariably a self-limited course).
Nakaharai K, Sakamoto Y, Yaita K, Yoshimura Y, Igarashi S, Tachikawa N. (2016). Drug-induced liver injury associated with high-dose ceftriaxone: a retrospective cohort study adjusted for the propensity score. Eur J Clin Pharmacol. (Retrospective analysis of 471 patients treated with ceftriaxone found that 15 [3.2%] developed abnormal liver tests within two weeks of treatment, including 16% receiving high dose [4 g daily] vs 2.1% receiving standard dose [2 g daily]).
Bonkovsky HL, Kleiner DE, Gu J, Odin JA, Russo MW, Navarro VM, Fontana RJ, et al., U.S. Drug Induced Liver Injury Network Investigators. (2017). Clinical presentations and outcomes of bile duct loss caused by drugs and herbal and dietary supplements. Hepatology. (Among 26 patients with drug induced liver injury and bile duct loss on liver biopsy, most developed severe cholestatic hepatitis an evidence of chronic residual liver injury suggestive of varying degrees of vanishing bile duct syndrome, 1 case was attributed to oral cephalexin and one to parenteral cefazolin but none to ceftriaxone).
Zhao Z, Bao L, Yu X, Zhu C, Xu J, Wang Y, Yin M, et al. (2017). Acute vanishing bile duct syndrome after therapy with cephalosporin, metronidazole, and clotrimazole: A case report. Medicine (Baltimore). (27 year old woman was treated with “cephalosporin”, metronidazole and clotrimazole after removal of an intrauterine device and developed evidence of liver injury several weeks later [bilirubin 1.7 mg/dL, ALT 335 U/L, Alk P 655 U/L], with persistence of jaundice for several months and liver biopsy showing paucity of bile ducts, but ultimate resolution of jaundice but persistence of mild Alk P elevations).
Low EXS, Zheng Q, Chan E, Lim SG. (2020). Drug induced liver injury: East versus West – a systematic review and meta-analysis. Clin Mol Hepatol. (Analysis of literature on causes of drug induced liver injury found that the most common causes from Asian reports were antituberculosis drugs [25%], phenytoin [3.5%], and cephalosporins [3%] while causes from European and American reports were most commonly amoxicillin/clavulanate [11%], nimesulide [6%], and ibuprofen [6%]).
Park JH, Hong S, Jun DW, Yoon JH, Lee KN, Lee HL, Lee OY, et al. (2021). Prevalence and clinical characteristics of antibiotics associated drug induced liver injury. Ann Transl Med. (Among 166 patients seen at a single Korean medical center over a 12 month period [2017-18] for serum enzyme elevations, 113 were attributed to drugs, including 78 [64%] to antibiotics, most frequently flomoxef [a cephalomycin, n=24], cetrazole [9], ceftriaxone [6], vancomycin [5], piperacillin-tazobactam [5], and amoxicillin/clavulanate [4], all of whom recovered upon stopping; unclear whether any were symptomatic or jaundiced).
Ferrajolo C, Verhamme KM, Trifirò G, 't Jong GW, Picelli G, Giaquinto C, Mazzaglia G, et al. (2017). Antibiotic-induced liver injury in paediatric outpatients: a case-control study in primary care databases. Drug Saf. (Among 938 cases of drug-associated liver injury in children identified in Italian and Dutch databases [with 93,665 controls] between 2000 and 2008, 138 arose after recent use of antibiotics including 26 linked to cephalosporins; cefaclor [n=8], cefixime [8], ceftriaxone [3], ceftibuten [3], cefpodoxime [2] and cefuroxime [1], the highest risk odds ratio being for ceftriaxone [14.7] and cefixime [6.1]).
Khurram D, Shamban L, Kornas R, Paul M. (2015). Marked direct hyperbilirubinemia due to ceftriaxone in an adult with sickle cell disease. Case Rep Gastrointest Med. (32 year old African American man with sickle cell disease during admission for an acute crisis and ceftriaxone and azithromycin therapy for suspected pneumonitis, had rise in total bilirubin levels from 3.3 to a peak of 17 mg/dL, which fell to baseline on switching antibiotics and resolution of the acute crisis; no direct bilirubin levels provided but increase was likely due to hemolysis and sepsis).

## OHTER REFERENCE LINKS

1 Recent References on Ceftriaxone: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=ceftriaxone/AE+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI+OR+hepatitis,+toxic%5BMH%5D))
2 Trials on Ceftriaxone: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=ceftriaxone)